# Eplontersen

## OVERVIEW

### Introduction

Eplontersen is transthyretin-directed antisense oligonucleoside used in the treatment of the polyneuropathy caused by hereditary transthyretin-mediated amyloidosis. Eplontersen has been associated with minor liver test abnormalities during therapy but has not been linked instances of clinically apparent liver injury.

### Background

Eplontersen (e plon’ ter sen) is an antisense oligonucleoside directed against transthyretin, a serum protein made in the liver whose major function is transport of vitamin A and thyroxine. Rare mutations in the transthyretin gene result in misfolding of the protein and accumulation of large amyloid deposits of transthyretin molecules, most prominently in peripheral nerves and the heart. Patients with hereditary transthyretin amyloidosis typically present with polyneuropathy or autonomic dysfunction followed by cardiomyopathy, which if untreated is usually fatal within 5 to 12 years. Eplontersen causes degradation of transthyretin and decreases production of both wild type and mutant forms in the liver resulting in lower serum concentrations and decreased accumulation in nerves and heart. Eplontersen is bound to a ligand with three N-acetyl galactosamine residues that direct the molecule for uptake by hepatocytes, where the majority of transthyretin is produced. In preregistration open label studies, eplontersen decreased transthyretin levels and led to improvements in symptoms of neuropathy as well as general quality of life, at least as compared to untreated historical controls. Studies in experimental animal models and in preliminary trials in humans suggest that long term therapy with eplontersen can prevent worsening of amyloid associated heart disease. Eplontersen was approved for use in the United States as treatment of polyneuropathy of hereditary transthyretin mediated amyloidosis in adults in 2023. It is available in solution as 45 mg in 0.8 mL in single use autoinjectors under the brand name Wainua. The usual dose regimen is 45 mg subcutaneously once per month. Side effects are infrequent but can include vomiting, proteinuria, injection site reactions, and blurred vision. Transthyretin is a vitamin A carrier involved in its transport and uptake. As a consequence, vitamin A levels decrease in patients receiving eplontersen. For that reason, while on treatment, patients should take supplements with the recommended daily allowance of vitamin A. Rare potential adverse events associated with eplontersen therapy include vitamin A deficiency and embryo-fetal toxicity.

### Hepatotoxicity

In the registration trial of eplontersen, liver test abnormalities occurred in 7.6% of treated patients, but the elevations were mild and no more frequent than was observed in a historical control group (6.7%). There were no ALT elevations above 3 times the upper limit of normal (ULN) and no case of aminotransferase elevations accompanied by jaundice or symptoms. Since its approval, clinical experience with eplontersen has been limited, but there have been no published case reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which eplontersen might cause liver injury is not clear. Eplontersen is an oligonucleotide and is metabolized to short sequences or individual nucleotides by plasma and intracellular nucleases. Eplontersen is not metabolized by P450 enzymes and has no effect on their level of activity and no significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on eplontersen therapy are unlikely to be due to the drug therapy and rarely require dose modification or discontinuation. Persistent ALT or AST elevations arising during therapy should lead to evaluation of their possible causes. There is no information on cross sensitivity to liver injury among the various other therapies for transthyretin-associated amyloidosis.

Drug Class: Genetic Disorder Agents

Drugs for Hereditary Transthyretin Amyloidosis: Acoramidis, Inotersen, Patisiran, Tafamidis, Vutrisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eplontersen – Wainua®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eplontersen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eplontersen | 1637600-16-8 | Nucleic Acid | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2025

Abbreviations: siRNA, small interfering RNA.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of antisense therapies such as eplontersen).
FDA. Integrated Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217388Orig1s000IntegratedR.pdf (FDA website with the product labels and integrated review of the data on efficacy and safety provided by the sponsor in support of approval of eplontersen as therapy of polyneuropathy due to transthyretin amyloidosis mentions that mild-to-moderate elevations in serum aminotransferase or alkaline phosphatase levels arose in 7.6% of eplontersen vs 6.7% of placebo recipients, but there were no ALT elevations above 3 times ULN and no cases of drug induced liver injury or aminotransferase elevations accompanied by jaundice).
Aimo A, Castiglione V, Rapezzi C, Franzini M, Panichella G, Vergaro G, Gillmore J, et al. RNA-targeting and gene editing therapies for transthyretin amyloidosis. Nat Rev Cardiol. 2022;19:655-667. (Review of the molecular approaches to therapy of transthyretin related amyloidosis including small interfering RNA [siRNA, patisiran, vutrisiran], antisense RNA [inotersen, eplontersen], CRISPR-Cas9 therapy, and molecular stabilization agents [acoramidis, tafamidis], some of which have been linked to minor serum aminotransferase elevations during therapy [vutrisiran, eplontersen], but not to clinically apparent liver injury). 35322226
Maurer MS. Overview of current and emerging therapies for amyloid transthyretin cardiomyopathy. Am J Cardiol. 2022;185 Suppl 1:S23-S34. (Review of approaches to therapy of amyloid transthyretin cardiomyopathy including the transthyretin stabilizers [tafamidis, acoramidis] and transthyretin gene silencing or knockdown agents [patisiran, vutrisiran, inotersen, eplontersen, CRISPR-Cas9]; no mention of liver related adverse events). 36371281
Coelho T, Marques W Jr, Dasgupta NR, Chao CC, Parman Y, França MC Jr, Guo YC, et al.; NEURO-TTRansform Investigators. Eplontersen for hereditary transthyretin amyloidosis with polyneuropathy. JAMA. 2023;330:1448-1458. (Among 168 adults with polyneuropathy and transthyretin amyloidosis treated with eplontersen vs placebo recipients [n=60] from a previous trial of inotersen, transthyretin levels decreased by 82% vs 11% and eplontersen treatment was associated with improvements in symptoms of neuropathy and quality of life, while adverse events arose in 97% vs 100%, severe events in 15% vs 20%, and discontinuations for adverse events in 6% vs 7%, and there were no cases of drug induced liver injury). 37768671
Nie T. Eplontersen: first approval. Drugs. 2024;84(4):473-478. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of eplontersen shortly after its approval as therapy of hereditary transthyretin amyloidosis in the US, mentions adverse events of decreases in vitamin A levels [95%], vitamin A deficiency [15%], vomiting, proteinuria, injection site reactions, blurred vision, and cataracts as well as rare events of atrioventricular heart block, and thrombocytopenia). 38413492
Masri A, Maurer MS, Claggett BL, Kulac I, Waddington Cruz M, Conceição I, Weiler M, et al. Effect of eplontersen on cardiac structure and function in patients with hereditary transthyretin amyloidosis. J Card Fail. 2024;30:973-980. (In a secondary analysis of the registration open label trial of eplontersen in patients with hereditary transthyretin amyloidosis [Coelho 2023] who had heart involvement, left ventricular ejection fraction and stroke volume improved slightly or was more likely to be stable in comparison to historical controls). 38065307

## OTHER REFERENCE LINKS

1. Recent References on Eplontersen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Eplontersen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Eplontersen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eplontersen)